# Quinupristin-Dalfopristin

## OVERVIEW

### Introduction

Quinupristin and dalfopristin are intravenously administered, streptogramin antibiotics used in fixed combination to treat severe bacterial infections due to susceptible organisms including methicillin resistant Staphylococcus aureus (MRSA). The fixed combination of quinupristin and dalfopristin is associated with a low rate of serum enzyme elevations during therapy but has not been convincingly linked to instances of clinically apparent liver injury.

### Background

Quinupristin (kwin" ue pris' tin) and dalfopristin (dal” foe pris’ tin) are streptogramin antibiotics that were initially isolated from Streptomyces pristinaspiralis. Quinupristin, a derivative of pristamycin IA, and dalfopristin, a derivative of pristamycin IIA, are synergistic in activity and are used in a fixed dose combination in a ratio of 30:70 by weight. This combination binds and inhibits the activity of the 50S subunit of bacterial ribosomes, which yields potent bactericidal activity against many gram positive bacteria including methicillin resistant forms of Staphylococcus aureus (MRSA). Quinupristin and dalfopristin also have activity against some gram negative bacteria including Enterococcus species. The combination of quinupristin and dalfopristin under the brand same of Synercid was approved for use in the United States in 1999. Current indications include complicated skin and skin structure infections caused by susceptible strains of Staphylococcus aureus or Streptococcus pyogenes and severe infections due to susceptible vancomycin-resistant Enterococcus faecium. The combination of quinupristin and dalfopristin is available in solution in 10 mL vials of 500 mg (150 mg of quinupristin and 350 mg of dalfopristin) and the typical dose regimen is 7.5 mg/kg intravenously every 8 to 12 hours for 5 to 14 days. Side effects may include nausea, diarrhea, headache, skin rash, myalgia, arthralgia and injection site reactions (burning, irritation, pain). Rare, but potentially severe side effects include anaphylaxis and angioneurotic edema.

### Hepatotoxicity

Elevations in serum aminotransferase levels occur in a proportion of patients receiving quinupristin and dalfopristin, but rates are minimally higher than with placebo or comparator drugs. The elevations are generally mild-to-moderate, asymptomatic and self-limited, frequently resolving without discontinuation or even interruption of therapy. Elevations above 5 times ULN occur in less than 1% of patients. Quinupristin-dalfopristin can also cause elevations in direct as well as total bilirubin, but these elevations are mild and not accompanied by elevations in serum enzymes or other evidence of liver injury. In the many clinical trials of quinupristin and dalfopristin there were no instances of clinically apparent liver injury that could be attributed convincingly to their use. Patients who receive quinupristin and dalfopristin are often severely ill, septic and receiving multiple medications or parenteral nutrition, so that jaundice arising during therapy is often multifactorial and difficult to assign to a specific cause. Nevertheless, since the approval and more wide spread use of this antibiotic combination, there have been no published reports of hepatitis or jaundice linked specifically to it use. Thus, clinically apparent liver injury from quinupristin and dalfopristin may occur, but is quite rare.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the mild-to-moderate serum aminotransferase elevations that occur during quinupristin and dalfopristin therapy is unknown. Both are extensively metabolized in the liver, largely via the cytochrome P450 system (CYP 3A4) and the combination is susceptible to drug-drug interactions with agents that are substrates for 3A4.

### Outcome and Management

The severity of the liver injury linked to quinupristin and dalfopristin therapy is usually mild and self-limited and dose modification or discontinuation is rarely necessary. No instances of acute liver failure, chronic hepatitis or vanishing bile duct syndrome have been attributed to quinupristin and dalfopristin therapy. Also, there is no information on cross sensitivity between quinupristin and dalfopristin and other antibiotics used for MRSA infections, but there is little reason to believe that such sensitivity exists.

Drug Class: Antiinfective Agents, Miscellaneous

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Quinupristin-Dalfopristin – Synercid®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Quinupristin-Dalfopristin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Quinupristin | 120138-50-3 | C53-H67-N9-O10-S | Quinupristin Chemical Structure
Dalfopristin | 112362-50-2 | C34-H50-N4-O9-S | Dalfopristin Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 21 May 2018

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immnosuppressive agents. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 673-708. (Expert review of hepatotoxicity published in 1999; does not discuss quinupristin-dalfopristin).
Moseley RH. Hepatotoxicity of antimicrobial and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd edition. Amsterdam: Elsevier, 2013. p. 463-81. (Expert review of antibiotic induced liver injury; does not discuss quinupristin or dalfopristin).
Raad I, Bompart F, Hachem R. Prospective, randomized dose-ranging open phase II pilot study of quinupristin/dalfopristin versus vancomycin in the treatment of catheter-related staphylococcal bacteremia. Eur J Clin Microbiol Infect Dis 1999; 18: 199-202. (Among 39 patients with Staphylococcal bacteremia due to intravenous catheters treated with quinupristin-dalfopristin or vancomycin, response rates were similar and side effects included arm and chest pain, fever, arthritis and phlebitis; no mention of ALT elevations or hepatotoxicity). 10357054
Moellering RC, Linden PK, Reinhardt J, Blumberg EA, Bompart F, Talbot GH. The efficacy and safety of quinupristin/dalfopristin for the treatment of infections caused by vancomycin-resistant Enterococcus faecium. Synercid Emergency-Use Study Group. J Antimicrob Chemother 1999; 44: 251-61. (Among 396 patients with vancomycin resistant Enterococcus faecium infections treated with quinupristin-dalfopristin, the overall response rate was 74% and arthralgia and myalgia were the most frequent adverse events and led to discontinuation in 6% of patients; only one patient had ALT elevations that required early discontinuation). 10473233
Rubinstein E, Prokocimer P, Talbot GH. Safety and tolerability of quinupristin/dalfopristin: administration guidelines. J Antimicrob Chemother 1999; 44 Suppl A: 37-46. (Pooled analysis of 2298 patients enrolled in 8 prospective studies of quinupristin-dalfopristin found common adverse events were arthralgia, nausea, diarrhea, and rash; serum direct bilirubin levels became elevated in 5.5% and bilirubin above 5 mg/dL in 1.5% of patients, but without concurrent serum enzyme elevations which were rarely elevated [ALT in 1.9% vs 3.8%, Alk P in 1% vs 2.7% receiving comparator drugs]). 10511396
Quinupristin/dalfopristin. Med Lett Drugs Ther 1999; 41 (1066): 109-10. (Concise review of the antibacterial activity, pharmacokinetics, clinical efficacy, safety and costs of quinupristin-dalfopristin shortly after its approval in the US mentions side effects of infusion site reactions, thrombophlebitis, allergic reactions, myalgia and occasional increases in serum direct bilirubin). 10987009
Fagon J, Patrick H, Haas DW, Torres A, Gibert C, Cheadle WG, Falcone RE, et al. Treatment of gram-positive nosocomial pneumonia. Prospective randomized comparison of quinupristin/ dalfopristin versus vancomycin. Nosocomial Pneumonia Group. Am J Respir Crit Care Med 2000; 161 (3 Pt 1): 753-62. (Among 198 patients with nosocomial pneumonia caused by gram-positive bacteria treated with either quinupristin-dalfopristin or vancomycin, both clinical response and adverse event rates were similar in the two groups; no mention of ALT elevations or hepatotoxicity). 10712318
Winston DJ, Emmanouilides C, Kroeber A, Hindler J, Bruckner DA, Territo MC, Busuttil RW. Quinupristin/Dalfopristin therapy for infections due to vancomycin-resistant Enterococcus faecium. Clin Infect Dis 2000; 30: 790-7. (Among 24 patients with vancomycin resistance Enterococcus faecium infections treated with quinupristin and dalfopristin, the only adverse events attributed to the drug were arthralgia and myalgia [33%] without CPK or aldolase elevations; no mention of ALT elevations or hepatotoxicity). 10817685
Drew RH, Perfect JR, Srinath L, Kurkimilis E, Dowzicky M, Talbot GH. Treatment of methicillin-resistant staphylococcus aureus infections with quinupristin-dalfopristin in patients intolerant of or failing prior therapy. For the Synercid Emergency-Use Study Group. J Antimicrob Chemother 2000; 46: 775-84. (Among 90 patients with MRSA infections who had failed or were intolerant to other antibiotic therapies and who were treated with quinupristin-dalfopristin, the overall response rate was 71% and common side effects were local venous infusion reactions, arthralgia, myalgia and nausea; no mention of ALT elevations or hepatotoxicity). 11062197
Linden PK, Bompart F, Gray S, Talbot GH. Hyperbilirubinemia during quinupristin-dalfopristin therapy in liver transplant recipients: correlation with available liver biopsy results. Pharmacotherapy 2001; 21: 661-8. (Among 25 liver transplant patients who developed a vancomycin-resistant Enterococcus faecium infection and received quinupristin-dalfopristin for 6-13 days and underwent liver biopsy, cholestasis was often found, but was also present before the antibiotic was started in many patients). 11401179
Carver PL, Whang E, VandenBussche HL, Kauffman CA, Malani PN. Risk factors for arthralgias or myalgias associated with quinupristin-dalfopristin therapy. Pharmacotherapy 2003; 23: 159-64. (Among 50 patients treated with quinupristin-dalfopristin at a single referral center between 1996 and 2000, 25 developed arthralgia or myalgia and factors that were associated with these symptoms were female sex, chronic liver disease, liver transplant, elevated serum bilirubin before starting therapy, major surgery and receipt of mycophenolate or cyclosporine). 12587804
Raad I, Hachem R, Hanna H, Afif C, Escalante C, Kantarjian H, Rolston K. Prospective, randomized study comparing quinupristin-dalfopristin with linezolid in the treatment of vancomycin-resistant Enterococcus faecium infections. J Antimicrob Chemother 2004; 53: 646-9. (Among 40 patients with cancer and vancomycin-resistant Enterococcus faecium infection treated with quinupristin-dalfopristin or linezolid, response rates were similar; and while quinupristin-dalfopristin treated subjects were more like to have myalgia or arthralgia [33% vs 0%], they had lower rates of nausea, serum bilirubin elevations and thrombocytopenia; no mention of ALT elevations or hepatotoxicity). 14998986
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, none were attributed to quinupristin-dalfopristin). 19132805
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to quinupristin-dalfopristin). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, but none were attributed to quinupristin-dalfopristin). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: the DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury in the US collected between 2004 and 2012, 323 cases were attributed to antibiotics, but none to quinupristin-dalfopristin). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Quinupristin-Dalfopristin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Quinupristin-Dalfopristin+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Quinupristin-Dalfopristin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Quinupristin-Dalfopristin)